# Defibrotide

## OVERVIEW

### Introduction

Defibrotide is a complex mixture of single stranded polydeoxyribonucleotides derived from porcine intestinal mucosa that has antithrombotic and profibrinolytic activity and is used in the treatment of severe sinusoidal obstruction syndrome (SOS) after hematopoietic cell transplantation (HCT). Defibrotide is used in patients with severe liver injury and has not been associated with worsening of serum aminotransferase elevations during therapy and has not been linked to cases of clinically apparent, idiosyncratic liver injury.

### Background

Defibrotide (de fib' roe tide) is a mixture of single stranded molecules of polydeoxyribonucleotides derived from porcine intestinal mucosa with molecular weights between 15,000 and 30,000 daltons. The short, single stranded DNA molecules have antithrombotic and profibrinolytic activities which suggested their use to treat SOS occurring after myeloablative regimens given in preparation of HCT. However, the pathophysiology of SOS involves destruction of sinusoidal endothelial centers in centrolobular (zone 3) regions along with stellate cell activation and deposition of collagen in sinusoids, and not thrombus formation. Thus, the mechanism of action of defibrotide in severe SOS is unknown, but it appears to act as an adenosine receptor agonist and as a stimulus to the production of endogenous prostaglandins, both of which modulate thrombogenesis and fibrinolysis. Defibrotide also binds to endothelial cells and may have cytoprotective activities on sinusoid cells or modulating effects on stellate cells. In multiple open label clinical trials, defibrotide was found to improve recovery of serum bilirubin elevations in SOS, but only in comparison to historical controls. Despite the lack of prospective, randomized controlled trials, defibrotide was approved for use in the United States in 2016 for severe SOS accompanied by evidence of renal or pulmonary failure occurring after myeloablation in preparation for HCT. Defibrotide is available as a solution for injection in single use vials of 200 mg/2.5 mL (80 mg/mL) under the brand name Defitelio. The recommended dose is 6.25 mg/kg every 6 hours for at least 21 days. Side effects include bleeding, hypotension, diarrhea, nausea and abdominal pain, but the typical patient receiving defibrotide is often critically ill with multiorgan failure and severe liver injury. Thus, minor and even fairly major side effects of defibrotide would be difficult to link to this therapy as opposed to the underlying severe, acute injury.

### Hepatotoxicity

Defibrotide therapy has not been linked to serum aminotransferase elevations or with instances of clinically apparent liver injury separate from the features of SOS for which it is given. In a trial of defibrotide as prophylaxis against SOS conducted in 356 children undergoing HCT, rates of severe adverse events such as hemorrhage, gastrointestinal complaints and liver injury were similar in those receiving defibrotide as in untreated children.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Defibrotide consists of a mixture of porcine polydeoxyribonucleotides which are unlikely to have a direct toxic effect on the liver and also unlikely to cause idiosyncratic metabolic or immunoallergic injury.

### Outcome and Management

No convincing instances of clinically apparent or severe acute liver injury have been linked to defibrotide in the published literature, and worsening of the underlying liver injury during therapy is generally considered due to the severity of the sinusoidal obstruction rather than drug induced injury. The appearance of excessive hemorrhage, however, is often a reason for early discontinuation of defibrotide.

Drug Class: Antithrombotic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Defibrotide – Defitelio®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Defibrotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Defibrotide | 83712-60-1 | Unspecified | Deoxyribonucleic Acid

## ANNOTATED BIBLIOGRAPHY

References updated: 27 December 2017

Abbreviations used: HCT, hematopoietic cell transplantation; SOS, sinusoidal obstruction syndrome (which was formerly called veno-occlusive disease: VOD).

Zimmerman HJ. Heparin. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999 before availability of defibrotide).
Weitz JI. Blood coagulation and anticoagulant, thrombolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Richardson PG, Elias AD, Krishnan A, Wheeler C, Nath R, Hoppensteadt D, Kinchla NM, et al. Treatment of severe veno-occlusive disease with defibrotide: compassionate use results in response without significant toxicity in a high-risk population. Blood 1998; 92: 737-44. (Among 19 patients with severe SOS after HCT [bilirubin 11.7 to 54.4 mg/dL] who were treated with defibrotide, 8 had an initial response and 5 were long term survivors; side effects included nausea, hypotension, bleeding, and abdominal cramping, and serious adverse events were common, but "a causative temporal relationship to any grade 3 or 4 toxicity with defibrotide could not be shown). 9680339
Chopra R, Eaton JD, Grassi A, Potter M, Shaw B, Salat C, Neumeister P, et al. Defibrotide for the treatment of hepatic veno-occlusive disease: results of the European compassionate-use study. Br J Haematol 2000; 111: 1122-9. (Among 40 patients with SOS after HCT treated with defibrotide [10 to 40 mg/kg daily] for 2-53 [median=14] days, 22 [55%] had complete resolution and 17 [43%] were long term survivors, response not correlating with daily or total dose; "defibrotide was safely administered with no significant side effects"). 11167751
Richardson PG, Murakami C, Jin Z, Warren D, Momtaz P, Hoppensteadt D, Elias AD, et al. Multi-institutional use of defibrotide in 88 patients after stem cell transplantation with severe veno-occlusive disease and multisystem organ failure: response without significant toxicity in a high-risk population and factors predictive of outcome. Blood 2002; 100: 4337-43. (Among 88 patients with severe SOS after HCT treated with defibrotide [5 to 60 mg/kg/day for 1-139 days], complete resolution occurred in 36% and therapy was "without significant toxicity"). 12393437
DeLeve LD, Shulman HM, McDonald GB. Toxic injury to hepatic sinusoids: sinusoidal obstruction syndrome (veno-occlusive disease). Seminars Liver Dis 2002; 22: 27-41. (Review of the clinical features, pathophysiology and management of SOS, formerly known as veno-occlusive disease, which appears to be due to toxic injury to sinusoidal endothelial cells which undergo necrosis, detachment and release into sinusoids with subsequent obstruction, collagen formation and obliteration of central [hepatic] veins). 11928077
Kornblum N, Ayyanar K, Benimetskaya L, Richardson P, Iacobelli M, Stein CA. Defibrotide, a polydisperse mixture of single-stranded phosphodiester oligonucleotides with lifesaving activity in severe hepatic veno-occlusive disease: clinical outcomes and potential mechanisms of action. Oligonucleotides 2006; 16: 105-14. (Review of the clinical features, pathogenesis and therapy of SOS focusing upon defibrotide, its structure, proposed mechanisms of action, clinical efficacy and safety: "in general no significant side effects occurred"). 16584299
Richardson PG, Soiffer RJ, Antin JH, Uno H, Jin Z, Kurtzberg J, Martin PL, et al. Defibrotide for the treatment of severe hepatic veno-occlusive disease and multiorgan failure after stem cell transplantation: a multicenter, randomized, dose-finding trial. Biol Blood Marrow Transplant 2010; 16: 1005-17. (Among 149 patients with severe SOS after HCT treated with defibrotide [25 or 40 mg/kg/day] for 2-85 [median = 19] days, resolution occurred in 49% and 43%, and adverse events were common [~90%] but only 3% were attributed to therapy [hypotension, hemorrhage], none of which were liver related). 20167278
Richardson PG, Ho VT, Giralt S, Arai S, Mineishi S, Cutler C, Antin JH, et al. Safety and efficacy of defibrotide for the treatment of severe hepatic veno-occlusive disease. Ther Adv Hematol 2012; 3: 253-65. (Review of safety and efficacy of defibrotide as therapy of severe SOS; mentions that in most studies there was "no significant toxicity"). 23606935
Corbacioglu S, Cesaro S, Faraci M, Valteau-Couanet D, Gruhn B, Rovelli A, Boelens JJ, et al. Defibrotide for prophylaxis of hepatic veno-occlusive disease in paediatric haemopoietic stem-cell transplantation: an open-label, phase 3, randomised controlled trial. Lancet 2012; 379 (9823): 1301-9. (Among 356 children undergoing myeloablation and HCT who were given prophylaxis with defibrotide or were not treated, SOS rates were somewhat less with treatment [12% vs 20%], but overall survival was the same; adverse event rates were also similar in the two groups including hemorrhage and gastrointestinal complaints; no mention of ALT elevations or hepatotoxicity). 22364685
Richardson PG, Riches ML, Kernan NA, Brochstein JA, Mineishi S, Termuhlen AM, Arai S, et al. Phase 3 trial of defibrotide for the treatment of severe veno-occlusive disease and multi-organ failure. Blood. 2016 Mar 31; 127 (13): 1656-65. (Among 102 adults with severe SOS after HCT treated with defibrotide [25 mg/kg] for 1-58 [median = 21.5] days, resolution by 100 days occurred in 25.5% compared to 12.5% in a matched, historical control group and adverse event rates were also similar). 26825712
Strouse C, Richardson P, Prentice G, Korman S, Hume R, Nejadnik B, Horowitz MM, et al. Defibrotide for treatment of severe veno-occlusive disease in pediatrics and adults: an exploratory analysis using data from the Center for International Blood and Marrow Transplant Research. Biol Blood Marrow Transplant 2016; 22: 1306-12. (In a retrospective analysis of 8341 patients who underwent HCT between 2008 and 2011 enrolled in an international database, 3.2% developed SOS, which was severe in 1.2% and included 41 defibrotide treated patients who were compared to 55 untreated subjects and had slightly, but not statistically significantly better survival [39% vs 31%], lower rates of graft-vs-host disease [23% vs 38%], but no differences in engraftment rates or other measures of safety). 27108694
Corbacioglu S, Carreras E, Mohty M, Pagliuca A, Boelens JJ, Damaj G, Iacobelli M, et al. Defibrotide for the treatment of hepatic veno-occlusive disease: final results from the International Compassionate-Use Program. Biol Blood Marrow Transplant 2016; 22: 1874-82. (Among 710 patients treated with defibrotide in an international compassionate use study, the 100+ day survival rate was 54% and adverse events were those largely due to multiorgan failure and graft vs host disease, while severe bleeding events occurred in 55 patients [8%] and were fatal in 37 [5%]). 27397724
Richardson PG, Riches ML, Kernan NA, Brochstein JA, Mineishi S, Termuhlen AM, Arai S, et al. Phase 3 trial of defibrotide for the treatment of severe veno-occlusive disease and multi-organ failure. Blood 2016; 127: 1656-65. (Among 102 patients with severe SOS after HCT treated with defibrotide, the 100+ daily survival was 38% which compared favorably to historical control rates [25%] while adverese event rates, including bleeding, were similiar). 26825712

## OTHER REFERENCE LINKS

1. Recent References on Defibrotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Defibrotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Defibrotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Defibrotide)